# Muscle Relaxants

## OVERVIEW

The skeletal muscle relaxants (Table) are a heterogeneous group of medications acting both centrally and peripherally to relieve muscle spasms. These medications have been in wide use for decades and rarely cause liver disease.

### COMMONLY USED MUSCLE RELAXANTS

Generic (Trade) Names | Generic (Trade) Names
Baclofen (Lioresal, Baclosan) | Metaxalone (Skelaxin)
Carisoprodol (Soma, Carisoma, Sodol) | Methocarbamol (Marbaxin, Robaxin)
Chlorzoxazone (Parafon Forte, Remular) | Orphenadrine (Flexon, Norgesic, Norflex)
Cyclobenzaprine (Flexeril) | Quinine
Dantrolene (Dantrium) | Tizanidine (Zanaflex)

Muscle relaxants are used to treat two different conditions: (1) spasticity from upper motor neuron syndromes as occurs in multiple sclerosis and (2) muscular pain or spasms from peripheral musculoskeletal diseases or injury such as low back pain. The muscle relaxants in current use have variable mechanisms of action, efficacy and adverse effects. This class of medications is well tolerated, with the most common side effects being drowsiness and nausea.

Muscle relaxants are said to be associated with asymptomatic elevations in serum aminotransferase levels in up to 5% of subjects, but the rate of such elevations may be the same in control, untreated subjects, and significant elevations (greater than 3 times the upper limit of normal) are rare. The majority of the published clinical trials evaluating the safety of muscle relaxants do not mention hepatotoxicity or aminotransferase elevations. Rare cases of drug induced jaundice have occurred with some, but not all of the muscle relaxants. Agents that have been fairly clearly linked to clinically apparent acute liver injury include chlorzoxazone, dantrolene, and tizanidine. Cases of acute liver failure and death have been reported after chlorzoxazone and dantrolene therapy. Very rare instances of clinically signficiant liver injury have been reported with quinine and baclofen. On the other hand, there is little evidence to suggest that carisoprodol, cyclobenzaprine, metaxalone, methocarbamol or orphenadrine are associated with significant liver injury and, if it occurs, hepatotoxicity from these agents must be exceedingly rare.

The following drug records are discussed individually and with specific references:

- Baclofen
- Carisoprodol
- Chlorzoxazone
- Cyclobenzaprine
- Dantrolene
- Metaxalone
- Methocarbamol
- Orphenadrine
- Tizanidine

## ANNOTATED BIBLIOGRAPHY

References updated: 30 January 2017

Zimmerman HJ. Muscle spasmolytics. In, Hepatotoxicity: The Adverse Effects of Drugs and Other Chemicals on the Liver. 2nd Ed. Philadelphia: Lippincott, 1999. p. 544-45. (Expert review of hepatotoxicity published in 1999 discusses dantrolene which causes overt liver injury [usually hepatocellular, sometimes fatal] in 0.4% of recipients, chlorzoxazone which was incriminated in at least 33 instances of liver injury [usually hepatocellular], and baclofen which has been used for decades, but specific reports of hepatic injury are scanty).
Hibbs RE, Zambon AC. Control of muscle spasms and rigidity. Agents acting at the neuromuscular junction and autonomic ganglia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s The pharmacological basis of therapeutics, 12th ed. New York: McGraw-Hill, 2011. p. 266-76. (Textbook of Pharmacology and Therapeutics).
Pinder RM, Brogden RN, Speight TM, Avery GS. Dantrolene sodium: a review of its pharmacological properties and therapeutic efficacy in spasticity. Drugs 1977; 13: 3-23. (Review of efficacy and safety of dantrolene; minor abnormalities in AST occur in 10% of patients and overt hepatitis in 0.35-0.5%). 318989
Utili R, Boitnott JK, Zimmerman HJ. Dantrolene-associated hepatic injury. Incidence and character. Gastroenterology 1977; 72 (4 Pt 1): 610-6. (A surveillance study of dantrolene safety in 2191 patients treated for >60 days; 1.8% developed "evidence of hepatic injury", 0.6% jaundice and 0.3% died: ~1% had to stop dantrolene due to hepatotoxicity and 2 of 5 who were restarted had a recurrence; recovery time ranged from 1 to 12 months and women were more likely to have liver injury than men. Analysis of ~30,000 patients taking long term dantrolene revealed 31 physician-reported cases of hepatotoxicity [0.1%], 16 [52%] being jaundiced and 11 [35%] fatal). 838213
Chui LK, Pelot D. Hepatic enzyme elevations associated with baclofen. Clin Pharm 1984; 3: 196-7. (Manufacturer reported than <1% of patients on baclofen developed AST elevations, but no case of hepatitis has found; a patient with traumatic quadriplegia and spasticity developed ALT elevations [414 U/L] 6 weeks after starting escalating doses of baclofen [80 mg/day], without symptoms or jaundice and levels fell to normal with decrease in dose). 6723229
Powers BJ, Cattau EL Jr, Zimmerman HJ. Chlorzoxazone hepatotoxic reactions. An analysis of 21 identified or presumed cases. Arch Intern Med 1986; 146: 1183-6. (Case report and review of FDA reports; 55 year old woman developed jaundice 3-4 weeks after starting chlorzoxazone [peak bilirubin 9.0 mg/dL, ALT 720 U/L] and had a positive rechallenge with fever, nausea and jaundice within a day of receiving one pill; in a review of 23 cases reported to the FDA, the average age was 45, latency was either <1 month or variable, enzyme pattern was usually hepatocellular; 60% of patients were jaundiced, 22% died). 3521519
Wallace JD. Summary of combined clinical analysis of controlled clinical trials with tizanidine. Neurology 1994; 44 (Suppl 9): S60-8; discussion S68-9. (Review of 525 patients treated with tizanidine in 3 controlled trials, 2 patients developed significant liver enzyme elevations, but many had "slight" abnormalities [all <10 times ULN] and all resolved with reduction of dosage or discontinuation). 7970013
de Graaf EM, Oosterveld M, Tjabbes T, Stricker BH. A case of tizanidine-induced hepatic injury. J Hepatol 1996; 25: 772-3. (55 year old woman developed jaundice 14 weeks after starting tizanidine [bilirubin 26.5 mg/dL, ALT 830 U/L, Alk P 187 U/L], resolving within 6 weeks of stopping and recurring after a single dose: tizanidine Case 1). 8938559
Groves L, Shellenberger MK, Davis CS. Tizanidine treatment of spasticity: a meta-analysis of controlled, double-blind, comparative studies with baclofen and diazepam. Adv Ther 1998; 15: 241-51. (Metaanalysis of 10 trials in 270 patients comparing baclofen and tizanidine, reported global tolerance, but no mention made of ALT abnormalities or hepatotoxicity). 10186943
Chou R, Peterson K, Helfand M. Comparative efficacy and safety of skeletal muscle relaxants for spasticity and musculoskeletal conditions: a systematic review. J Pain Symptom Manage 2004; 28: 140-75. (Thorough review of the pharmacology, efficacy and side effects of the muscle relaxants). 15276195
Toth PP, Urtis J. Commonly used muscle relaxant therapies for acute low back pain: a review of carisoprodol, cyclobenzaprine hydrochloride, and metaxalone. Clin Ther 2004; 26: 1355-67. (Review of safety and efficacy of muscle relaxants which states "Although rare instances of hepatic enzyme elevation and anemia have been reported [with metaxalone], this association appears to be based on a false-positive hepatic assay using the cephalin flocculation test."). 15530999
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to a specific muscle relaxant). 15390328
Jackson J, Anania FA. Chlorzoxazone as a cause of acute liver failure requiring liver transplantation. Dig Dis Sci 2007; 52: 3389-91. (38 year old woman developed acute liver failure requiring transplant after 6 weeks of chlorzoxazone [bilirubin 17.9 mg/dL, ALT 1014 U/L, Alk P not given, INR 3.6]; first report in ~10 years). 17390222
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, one was attributed to chlorzoxazone, but no other muscle relaxant was mentioned). 18955056
Caruso A, Vecchio R, Patti F, Neri S. Drug rash with eosinophilia and systemic signs syndrome in a patient with multiple sclerosis. Clinical Therapeutics 2009; 31: 580-4. (44 year old woman developed drug rash with eosinophilia and jaundice 8 weeks after starting baclofen, mitoxantrone, and piracetam [bilirubin 19.3 mg/dL, ALT 561 U/L, Alk P 705 U/L], resolving within 6 months of stopping all 3 drugs; causality assessment implicated mitoxantrone [a toposiomerase inhibitor used to treat multiple sclerosis]). 19393848
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to muscle relaxants). 20949552
Macaigne G, Champagnon N, Harnois F, Cheiab S, Chayette C. Baclofen-induced acute hepatitis in alcohol-dependent patient. Clin Res Hepatol Gastroenterol 2011; 35: 420-1. (46 year old woman with alcoholism developed rise in serum ALT [from 1.5 to 6.5 times ULN] and AST [from 5.5 to 9 times ULN], with no change in bilirubin or Alk P 1 week after starting baclofen, values falling to normal within 6 weeks of stopping). 21561828
Kim JY, Chun S, Bang MS, Shin HI, Lee SU. Safety of low-dose oral dantrolene sodium on hepatic function. Arch Phys Med Rehabil 2011; 92: 1359-63. (Retrospective analysis of serial liver test results in 92 patients treated with at least 4 weeks dantrolene found no change in average ALT, AST or Alk P; one 32 year old man with HBsAg had ALT elevations before therapy and had a rise in Alk P and bilirubin during treatment with partial improvement upon stopping). 21878205
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013 ; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to muscle relaxants). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases; no cases were attributed to muscle relaxants). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 [0.7%] were attributed to muscle relaxants, including two to dantrolene and one each from baclofen, metaxalone and tizanidine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Muscle Relaxants: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=muscle+relaxants,+central/AE+AND+human%5Bmh%5D+AND+(drug-induced+liver+injury+OR+liver+diseases/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+jaundice/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/12/01%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Muscle Relaxants: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=muscle+relaxants)